# Midostaurin

## OVERVIEW

### Introduction

Midostaurin is an orally available small molecule inhibitor of FMS-like tyrosine kinase 3 (FLT3) which is used as an antineoplastic agent in the treatment of acute myeloid leukemia with FLT3 mutations. Midostaurin is associated with a moderate rate of serum aminotransferase elevations during therapy and is suspected to cause rare instances of clinically apparent acute liver injury.

### Background

Midostaurin (mye" doe staw' rin) is a potent small molecule multi-kinase inhibitor with specific activity against FLT3 (FMS-like tyrosine kinase 3), a tyrosine kinase receptor that is mutated in to up one-third of patients with acute myeloid leukemia (AML). The mutated FLT3 activates an intracellular signaling cascade of RAS-MEK-PI3K-AKT-STAT-5, promoting unregulated cell growth and proliferation. Midostaurin also has activity against other kinases including Kit, platelet derived growth factor receptor, vascular endothelial growth factor receptor 2 and members of the protein kinase C family. Midostaurin has been found to induce objective responses in a proportion of patients with refractory AML with detectable FLT3 mutations and in patients with advanced systemic mastocytosis. Midostaurin received accelerated approval for these indication in the United States in 2017 and is available in tablets of 25 mg under the brand name Rydapt. For newly diagnosed AML with FLT3 mutations, the recommended dose is 50 mg orally twice daily in combination with standard cytarabine and daunorubicin induction and cytarabine consolidation. For advanced systemic mastocytosis, the recommended dose is 100 mg orally twice daily, continued until progressive disease or intolerable toxicity occurs. Side effects are common and can include fatigue, myalgia, arthralgia, fever, cytopenias, diarrhea, nausea, abdominal pain, dizziness, headache, hypotension, cough and stomatitis. Potentially severe side effects include febrile neutropenia and sepsis, interstitial lung disease and embryo-fetal toxicity.

### Hepatotoxicity

Elevations in serum aminotransferase levels are common during midostaurin therapy occurring in up to 71% of patients with AML also receiving standard induction therapy and rising above 5 times the upper limit of the normal range in 20%. In patients with systemic mastocytosis receiving midostaurin monotherapy, ALT elevations arose in 31% of patients and rose to above 5 times ULN in 4%. Hyperbilirubinemia was also common in these studies but instances of clinically apparent liver injury with jaundice, severe hepatoxicity and deaths from hepatic failure were not reported. However, because of the limited clinical experience with the use of midostaurin and other FLT3 inhibitors, their potential for causing liver injury is not well defined.

Likelihood score: E* (unproven but suspected cause of clinically apparent liver injury).

### Mechanism of Injury

The possible cause of the liver injury due to midostaurin is not known. Midostaurin is metabolized in the liver largely by the cytochrome P450 system (largely CYP 3A4) and is susceptible to drug-drug interactions with inhibitors or inducers of the microsomal enzyme system, and strong modulators of CYP 3A4 should be avoided in patients receiving midostaurin.

### Outcome and Management

Midostaurin therapy has been associated with transient serum aminotransferase elevations during therapy but has not been linked to instances of acute liver injury with jaundice or symptoms. Serum aminotransferase elevations above 5 times the upper limit of normal (if confirmed) should lead to temporary discontinuation, which should be permanent if laboratory values do not improve significantly or resolve within a few weeks or if symptoms or jaundice arise.

Drug Class: Antineoplastic Agents, Protein Kinase Inhibitors

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Midostaurin – Rydapt®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Midostaurin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Midostaurin | 120685-11-2 | C35-H30-N4-O | Midostaurin structure

## ANNOTATED BIBLIOGRAPHY

References updated: 10 April 2019

Abbreviations: FLT3, FMS-like tyrosine kinase-3; AML, acute myelogenous leukemia.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of kinase inhibitors).
DeLeve LD. Erlotinib. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 556. (Review of hepatotoxicity of cancer chemotherapeutic agents published in 2013 before the availability of midostaurin).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway-targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL, Hilal-Danan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
https://www.accessdata.fda.gov/scripts/cder/daf/ (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA scientific review of the new drug application for safety and efficacy; mentions that ALT elevations arose in similar proportions of patients receiving midostaurin as placebo during induction therapy of AML [69% vs 68%] but elevations above 5 times ULN were more frequent with midostaurin [20% vs 16%] although ALT elevations with hyperbilirubinemia were less frequent [3% vs 5%]).
Gotlib J, Kluin-Nelemans HC, George TI, Akin C, Sotlar K, Hermine O, Awan FT, et al. Efficacy and safety of midostaurin in advanced systemic mastocytosis. N Engl J Med 2016; 374: 2530-41. (Among 116 patients with advanced systemic mastocytosis treated with midostaurin in an open-label study, the objective response rate was 56% and adverse events were frequent including nausea [79%], diarrhea [54%] and cytopenias; no mention of ALT elevations or hepatotoxicity and no discontinuations for liver injury). 27355533
Midostaurin (Rydapt) for AML and advanced systemic mastocytosis. Med Lett Drugs Ther 2017; 59 (1527): e140. (Concise review of the trials showing efficacy and safety of midostaurin in systemic mastocytosis shortly after its approval for this indication in the US mentions adverse events of febrile neutropenia, nausea, vomiting and mucositis, but not ALT elevations or hepatotoxicity). 28787746
Perl AE, Altman JK, Cortes J, Smith C, Litzow M, Baer MR, Claxton D, et al. Selective inhibition of FLT3 by gilteritinib in relapsed or refractory acute myeloid leukaemia: a multicentre, first-in-human, open-label, phase 1-2 study. Lancet Oncol 2017; 18: 1061-75. (Among 252 adults with refractory or relapsed AML treated with different doses of gilteritinib, responses occurred in 40% and complete remission in 8%; adverse events were frequent including febrile neutropenia, sepsis, and pneumonia, while ALT elevations arose in 18% of recipients which were above 5 times ULN in 5%, but there were no instances of clinically apparent liver injury).
Fathi AT, Chen YB. The role of FLT3 inhibitors in the treatment of FLT3-mutated acute myeloid leukemia. Eur J Haematol 2017; 98: 330-6. (Review of the role of mutated FLT3 in AML and efficacy of drugs with potent, specific activity against FLT3 in AML, including sorafenib, quizartinib, crenolanib and gilteritinib, as well as the nonspecific tyrosine kinase inhibitors with some activity against FLT3 such as midostaurin, sunitinib and sorafenib). 28000291
Stone RM, Mandrekar SJ, Sanford BL, Laumann K, Geyer S, Bloomfield CD, Thiede C, et al. Midostaurin plus chemotherapy for acute myeloid leukemia with a FLT3 mutation. N Engl J Med 2017; 377: 454-64. (Among 717 patients with AML and FLT3 mutations treated with standard chemotherapy with or without midostaurin, median overall survival was longer in midostaurin treated patients [75 vs 32 months], while adverse event rates were similar in the two groups including febrile neutropenia [82% vs 82%], ALT elevations [13% vs 9%] and hyperbilirubinemia [7% vs 8%]). 28644114
Kasamon YL, Ko CW, Subramaniam S, Ma L, Yang Y, Nie L, Shord S, et al. FDA approval summary: midostaurin for the treatment of advanced systemic mastocytosis. Oncologist 2018; 23: 1511-9. (Review of the open-label clinical trial that was the basis for approval of midostaurin for advanced systemic mastocytosis during which 56% of patients had dose interruptions and 21% discontinuation for adverse events; no mention of ALT elevations or hepatotoxicity). 30115735
Click ZR, Seddon AN, Bae YR, Fisher JD, Ogunniyi A. New Food and Drug Administration-approved and emerging novel treatment 0ptions for acute myeloid leukemia. Pharmacotherapy 2018; 38: 1143-54. (Review of recently developed targeted antineoplastic agents active in treating AML including midostaurin, the first FLT3-targeted therapy for AML; no mention of ALT elevations or hepatotoxicity). 30220082
Kim M, Williams S. Midostaurin in combination with standard chemotherapy for treatment of newly diagnosed FMS-like tyrosine kinase 3 (FLT3) mutation-positive acute myeloid leukemia. Ann Pharmacother 2018; 52: 364-9. (Review of the efficacy and safety of midostaurin combined with standard induction chemotherapy for AML; mentions frequency of adverse events and severe adverse events of febrile neutropenia, pulmonary fibrosis, drug-drug interactions and embryo-fetal toxicity, but not hepatotoxicity or ALT elevations). 29231051
DeAngelo DJ, George TI, Linder A, Langford C, Perkins C, Ma J, Westervelt P, et al. Efficacy and safety of midostaurin in patients with advanced systemic mastocytosis: 10-year median follow-up of a phase II trial. Leukemia 2018; 32: 470-8. (Among 26 patients with advanced systemic mastocytosis treated with midostaurin for up to 10 years, no new or unexpected toxicity arose; no mention of ALT elevations or hepatotoxicity). 28744009

## OTHER REFERENCE LINKS

1. Recent References on Midostaurin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Midostaurin+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Midostaurin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Midostaurin)